# Plerixafor

## OVERVIEW

### Introduction

Plerixafor is a small molecular antagonist of the cell-surface CXCR4 receptor that plays an important role in mobilization of hematopoietic stem and progenitor cells to the stroma of the bone marrow; blocking the receptor helps to mobilize stem cells from the marrow to peripheral blood allowing for collection of these cells by apheresis for hematopoietic cell transplantation. Plerixafor is generally well tolerated and has not been linked to serum enzyme elevations or to clinically apparent liver injury.

### Background

Plerixafor (pler ix' a for) is a small molecule antagonist of CXCR4 that blocks its down-steam signaling and results in release of CD34+ hematopoietic stem and progenitor cells from the bone marrow, enabling their collection by apheresis to be used in hematopoietic cell transplantation. In multiple clinical studies, the combination of plerixafor with granulocyte-colony stimulating factor (G-CSF) resulted in greater mobilization in CD34+ cells than G-CSF alone and more successful retrieval of hematopoietic stem cells from donors and better engraftment in recipients. Plerixafor, in combination with G-CSF, was approved for use in mobilizing hematopoietic stem cells for autologous transplantation in patients with non-Hodgkin lymphoma and multiple myeloma in the United States in 2008 and it has become commonly used for both allogeneic and autologous hematopoietic cell transplantation. Plerixafor is available in solution in 1.2 mL single-use vials of 20 mg/mL. The recommended dose is 0.24 mg/kg after the patient or potential donor has received G-CSF once daily for 4 days. The dose of plerixafor can be repeated for up to 4 days. Common adverse reactions include diarrhea, nausea, fatigue, injection site reactions, headache, dizziness and arthralgia. Rare, but potential severe adverse reactions include tumor cell mobilization in leukemia patients, splenic rupture and fetal-embryonal toxicity.

### Hepatotoxicity

Plerixafor has not been linked to instances of significant serum enzyme elevations during therapy nor to cases of clinically apparent liver injury. In multiple large prelicensure as well as postmarketing controlled trials, neither ALT elevations or acute liver injury were mentioned as adverse events or reasons for drop out, early discontinuation of therapy or dose modification. There have been no published reports of liver injury attributed to plerixafor, and it has been used as a possible means of treatment in animal models of acute liver failure. Thus, clinically apparent liver injury due to plerixafor must be rare, if it exists at all.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which plerixafor might cause liver injury is not known. It is given in low total dosage for 1 to 4 days only.

### Outcome and Management

Serum aminotransferase elevations above 5 times the upper limit of normal arising de novo during hematopoietic cell mobilization should lead to discontinuation. Plerixafor has not been implicated in causing clinically apparent hepatitis, acute liver failure, chronic hepatitis or vanishing bile duct syndrome. There is no reason to suspect any degree of cross sensitivity in risk for hepatic injury among the various hematologic growth factors and other agents used to mobilize blood marrow cells.

Drug Class: Hematologic Agents, Transplant Agents

Other Drugs in the Class, Transplant Agents: Cyclosporine, Everolimus, Mycophenolate, Sirolimus

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Plerixafor – Mozobil®

DRUG CLASS

Transplant Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Plerixafor)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Plerixafor | 110078-46-1 | C28-H54-N8 | Plerixafor Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 12 April 2019

Abbreviations: G-CSF, granulocyte colony stimulating factor; HCT, hematopoietic cell transplantation.

Zimmerman HJ. Hormonal derivatives and related drugs. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Textbook of hepatotoxicity published in 1999; plerixafor is not mentioned).
Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013. (Textbook on hepatotoxicity; plerixafor is not discussed).
Kaushansky K, Kipps TJ. Hematopoietic agents: growth factors, minerals, and vitamins. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 751-68. (Textbook of pharmacology and therapeutics).
https://www.accessdata.fda.gov/scripts/cder/daf/ (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy; does not mention or discuss serum enzyme elevations or hepatotoxicity).
Stahel RA, Jost LM, Cerny T, Pichert G, Honegger H, Tobler A, Jacky E, Fey M, Platzer E. Randomized study of recombinant human granulocyte colony-stimulating factor after high-dose chemotherapy and autologous bone marrow transplantation for high-risk lymphoid malignancies. J Clin Oncol 1994; 12: 1931-8. (Among 43 patients with lymphomas undergoing chemotherapy and hematopoietic cell transplant ation [HCT] given filgrastim in two different doses, efficacy and tolerance were similar and the only adverse events attributed to the G-CSF were bone pain and skin reactions). 7521907
DiPersio JF, Stadtmauer EA, Nademanee A, Micallef IN, Stiff PJ, Kaufman JL, Maziarz RT, et al.; 3102 Investigators. Plerixafor and G-CSF versus placebo and G-CSF to mobilize hematopoietic stem cells for autologous stem cell transplantation in patients with multiple myeloma. Blood 2009; 113: 5720-6. (Among 308 patients with multiple myeloma who were eligible for autologous HCT and received G-CSF for 4 days followed by G-CSF with plerixafor or placebo for 1-4 days, successful mobilization of CD34+ cells was more frequent and more rapid with plerixafor, but 1 year survival was the same as were rates of adverse events, no mention of ALT elevations or hepatotoxicity). 19363221
DiPersio JF, Uy GL, Yasothan U, Kirkpatrick P. Plerixafor. Nat Rev Drug Discov 2009; 8: 105-6. (Short review of the mechanism of action of plerixafor and its use in mobilizing hematopoietic stem cells for transplantation). 19180104
DiPersio JF, Micallef IN, Stiff PJ, Bolwell BJ, Maziarz RT, Jacobsen E, Nademanee A, et al.; 3101 Investigators. Phase III prospective randomized double-blind placebo-controlled trial of plerixafor plus granulocyte colony-stimulating factor compared with placebo plus granulocyte colony-stimulating factor for autologous stem-cell mobilization and transplantation for patients with non-Hodgkin's lymphoma. J Clin Oncol 2009; 27: 4767-73. (Among 298 patients with non-Hodgkin lymphoma eligible for HCT who underwent stem cell mobilization with G-CSF and either plerixafor or placebo, successful and rapid mobilization was more frequent with plerixafor [59% vs 20%], while common adverse events included diarrhea [38% vs 6%], nausea [17% vs 6%], abdominal pain [6% vs 1%], injection site reactions, bone pain [11% vs 7%] and headache [11% vs 6%], no mention of ALT elevations or hepatotoxicity). 19720922
Plerixafor (Mozobil). Med Lett Drugs Ther 2010; 52 (1335): 27-8. (Concise review of the mechanism of action, clinical efficacy, safety and costs of plerixafor shortly after its approval for use in the US; does not mention ALT elevations or hepatotoxicity). 20360661
Brave M, Farrell A, Ching Lin S, Ocheltree T, Pope Miksinski S, Lee SL, Saber H, et al. FDA review summary: Mozobil in combination with granulocyte colony-stimulating factor to mobilize hematopoietic stem cells to the peripheral blood for collection and subsequent autologous transplantation. Oncology 2010; 78: 282-8. (An FDA review of the clinical efficacy and safety of plerixafor from two large, registration trials that led to its approval for mobilization of hematopoietic stem cells for use in autologous HCT; no mention of ALT elevations or hepatotoxicity). 20530974
Lemery SJ, Hsieh MM, Smith A, Rao S, Khuu HM, Theresa D, Viano JM, et al. A pilot study evaluating the safety and CD34+ cell mobilizing activity of escalating doses of plerixafor in healthy volunteers. Br J Haematol 2011; 153: 66-75. (Among 21 healthy volunteers who received 1 to 2 single doses of plerixafor, common adverse events included diarrhea, bloating, nausea, injection site reactions, headache and peroral numbness). 21352197
Russell N, Douglas K, Ho AD, Mohty M, Carlson K, Ossenkoppele GJ, Milone G, et al. Plerixafor and granulocyte colony-stimulating factor for first-line steady-state autologous peripheral blood stem cell mobilization in lymphoma and multiple myeloma: results of the prospective PREDICT trial. Haematologica 2013; 98: 172-8. (Among 118 patients with non-Hodgkin lymphoma or multiple myeloma undergoing stem cell mobilization in preparation for autologous HCT who received G-CSF and plerixafor, treatment emergent events included diarrhea, nausea, injection-site reactions and bone pain; no mention of ALT elevations or hepatotoxicity). 22983579
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: the DILIN prospective study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury seen over a ten-year period at 8 US medical centers, none were attributed to the agents used for hematopoietic stem cell mobilization). 25754159
Pantin J, Purev E, Tian X, Cook L, Donohue-Jerussi T, Cho E, Reger R, et al. Effect of high-dose plerixafor on CD34(+) cell mobilization in healthy stem cell donors: results of a randomized crossover trial. Haematologica 2017; 102: 600-9. (Among 23 healthy subjects receiving plerixafor [240 or 480 µg/kg], the higher dose resulted in higher peak numbers of CD34+ cells in peripheral blood and adverse event rates were similar, only one subject [after the lower dose] had a mild and transient ALT elevation). 27846612
Ahmadi AR, Chicco M, Wesson RN, Anders RA, Dor FJMF, Ijzermans JNM, Creamer TJ, et al. Stem cell mobilization is lifesaving in a large animal preclinical model of acute liver failure. Ann Surg 2018; 268: 620-31. (In a pig model of acute liver failure induced by d-galactosamine, administration of G-CSF and plerixafor at 0, 1 and 2 days was associated with higher survival and less severe hepatic injury). 30102635
Chen YB, Le-Rademacher J, Brazauskas R, Kiefer DM, Hamadani M, DiPersio JF, Litzow MR, et al. Plerixafor alone for the mobilization and transplantation of HLA-matched sibling donor hematopoietic stem cells. Blood Adv 2019; 3: 875-83. (Among 64 healthy donors receiving a single dose of plerixafor alone [240 µg/kg] followed by leukapheresis 4 hours later, adequate mobilization of CD4+ cells was achieved in 98% and adverse events were generally mild; no mention of ALT elevations or hepatotoxicity). 30890544

## OTHER REFERENCE LINKS

1. Recent References on Plerixafor: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Plerixafor/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Plerixafor: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Plerixafor)